# Triheptanoin

## OVERVIEW

### Introduction

Triheptanoin is synthetic, medium-chain triglyceride that was developed for nutritional support of patients with long-chain fatty acid oxidation disorders. Triheptanoin is given orally by feeding tube titrated to provide approximately 30% of calories. Triheptanoin therapy has not been associated with elevations in serum aminotransferase or bilirubin levels or to instances of clinically apparent liver injury.

### Background

Triheptanoin (trye hep’ ta noyn) is a synthetic, purified medium-chain triglyceride that has three 7-carbon chain length fatty acids that is used as a source of calories and fatty acids for adults and children with long-chain fatty acid oxidation disorders (LC-FAOD). The LC-FAODs are rare autosomal recessive disorders caused by defects in the mitochondrial enzymes that metabolize fatty acids, which results in the inability to break down long-chain fatty acids to produce energy and support protein synthesis. In addition, the undigested long-chain fatty acids accumulate and can be toxic to cells. Patients with LC-FAOD suffer from recurrent bouts of muscle pain, rhabdomyolysis, hypoglycemia, liver disease, and cardiomyopathy. The standard therapy is a rigorous diet avoiding fasting and restricting fat intake along with nutritional supplements of food grade medium-chain triglycerides (MCT), which are typically a mixture of triglycerides with 6, 8, 10 or 12 carbon chain fatty acids. In clinical trials in patients with LD-FAOD, triheptanoin was as effective as standard MCT in reducing the number of major clinical events and hospitalizations. Triheptanoin was approved as a source of calories and fatty acids for adults and children with documented LC-FAOD in 2020. Triheptanoin is available as an oral liquid which is diluted with foods, liquids or formula and administered by feeding tube. The dose is titrated attempting to achieve provision of 30% to 35% of the daily caloric intake. Adverse events include abdominal pain, diarrhea, bloating, nausea, and vomiting as well as feeding tube dysfunction. Rare but potentially severe adverse events include pancreatitis. Management of patients with LC-FAOD requires expertise in nutrition and careful monitoring of diet, caloric and fat intake, and the many complications of the disease.

### Hepatotoxicity

Serum enzyme elevations during triheptanoin therapy are frequent, mostly reflecting the underlying condition of muscle and hepatic accumulation of toxic fatty acid products and lack of adequate energy production. Elevations in CPK were present in 81%, ALT in 72% and AST in 68% of subjects treated in preregistration studies. The elevations were greater than 5 times the upper limit of normal (ULN) of CPK in 47%, ALT in 24% and AST in 15%. Nevertheless, the changes were not considered due to the triheptanoin or MCT therapy but rather to the underlying metabolic disorder and mitochondrial dysfunction. In small trials of triheptanoin in other genetic metabolic diseases, laboratory values were reported to be unchanged during supplementation. Since its approval and more widescale use, there have been no published cases of clinically apparent liver injury attributed to triheptanoin therapy, although its total clinical experience with its use has been limited.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Triheptanoin is a pure, pharmaceutical grade, synthetic medium-chain triglyceride with three 7 carbon fatty acid chains. There is no evidence that it causes liver injury but is used in patients who frequently have serum aminotransferase elevations.

### Outcome and Management

The product label for triheptanoin does not recommend monitoring of routine liver tests during therapy. It is prudent to monitor routine liver tests before starting triheptanoin because preexisting abnormalities are frequent, and elevations found during therapy should be compared to pretreatment values.

Drug Class: Nutritional Supplements

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Triheptanoin – Dojolvi®

DRUG CLASS

Nutritional Supplements

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Triheptanoin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Triheptanoin | 620-67-7 | C24-H44-O6

## ANNOTATED BIBLIOGRAPHY

References updated: 10 June 2024

Abbreviations: LC-FAOD, long-chain fatty acid oxidation disorders; MCT, medium-chain triglycerides; ULN, upper limit of normal range.

FDA. Integrated Review. 2020.
https://www.accessdata.fda.gov/drugsatfda_docs/nda/2020/213687Orig1s000IntegratedR.pdf (FDA website with integrated review of data on triheptanoin safety and efficacy submitted in support of the application for approval as therapy of long-chain fatty acid oxidation disorders (LC-FAOD), mentions laboratory abnormalities found during therapy include elevations in CPK [71%], ALT [72%], and AST [67%] which are greater than 5 times the ULN in 47%, 24%, and 15%, the elevations however, were attributed to the underlying disease not to triheptanoin).
Vockley J, Marsden D, McCracken E, DeWard S, Barone A, Hsu K, Kakkis E. Long-term major clinical outcomes in patients with long chain fatty acid oxidation disorders before and after transition to triheptanoin treatment--A retrospective chart review. Mol Genet Metab. 2015;116(1-2):53-60. (In a retrospective analysis of 29 patients with LC-FAOD treated with triheptanoin [providing 28% of daily caloric intake] for 78 weeks, the annualized rate of major clinical events [rhabdomyolysis, hypoglycemia, myocardiopathy] decreased by 48% compared to previous therapy with standard MCT [providing 17% of daily caloric intake]; no mention of adverse events). 26116311
Gillingham MB, Heitner SB, Martin J, Rose S, Goldstein A, El-Gharbawy AH, Deward S, et al. Triheptanoin versus trioctanoin for long-chain fatty acid oxidation disorders: a double blinded, randomized controlled trial. J Inherit Metab Dis. 2017;40:831-843. (Among 32 patients with LC-FAOD treated with either triheptanoin or trioctanoin for 4 months, slight improvements in cardiac function was found with the 7 carbon but not the 8 carbon triglyceride, while adverse events were similar with the two products; no mention of ALT elevations or hepatotoxicity). 28871440
Hainque E, Caillet S, Leroy S, Flamand-Roze C, Adanyeguh I, Charbonnier-Beaupel F, Retail M, et al. A randomized, controlled, double-blind, crossover trial of triheptanoin in alternating hemiplegia of childhood. Orphanet J Rare Dis. 2017;12:160. (Among 10 patients with alternating hemiplegia of childhood treated with triheptanoin or placebo in a cross-over design, there were no differences in paroxysmal events between the treatment and placebo periods and adverse event rates were similar [50% vs 70%] and triheptanoin was considered “well tolerated”; no mention of ALT elevations or hepatotoxicity). 28969699
Vockley J, Burton B, Berry GT, Longo N, Phillips J, Sanchez-Valle A, Tanpaiboon P, et al. UX007 for the treatment of long chain-fatty acid oxidation disorders: Safety and efficacy in children and adults following 24 weeks of treatment. Mol Genet Metab. 2017;120:370-377. (Among 29 patients with LC-FAOD treated with triheptanoin for 24 weeks, improvements in exercise tests occurred in most patients tested and adverse events were frequent, most commonly diarrhea, nausea, vomiting and abdominal pain; no mention of ALT elevations or hepatotoxicity). 28189603
Schiffmann R, Wallace ME, Rinaldi D, Ledoux I, Luton MP, Coleman S, Akman HO, et al. A double-blind, placebo-controlled trial of triheptanoin in adult polyglucosan body disease and open-label, long-term outcome. J Inherit Metab Dis. 2018;41:877-883. (Among 19 patients with adult polyglucosan body disease treated with triheptanoin or vegetable oil for one year, there were no differences in changes in 6-minute walk test or in adverse event rates, most of which were considered unrelated to the therapy; no mention of ALT elevations or hepatotoxicity). 29110179
Merritt JL 2nd, Norris M, Kanungo S. Fatty acid oxidation disorders. Ann Transl Med. 2018;6:473. (Review of fatty acid oxidation disorders, a series of rare [1:5000-1:10,000 births] severe autosomal recessive conditions due to inability to metabolize fatty acids to enter the citric acid cycle for energy production; having variable presentations, neonatally typically with cardiomyopathy, in childhood with hypoglycemia and liver dysfunction [Reyes-like syndrome of acute fatty liver], in adolescence with episodic rhabdomyolysis; treated with avoidance of fasting, a fat-restricted diet, aggressive treatment of intercurrent illnesses, and for LC-FAOD, supplementation with MCT; no discussion of adverse events with therapies). 30740404
Borges K, Kaul N, Germaine J, Kwan P, O'Brien TJ. Randomized trial of add-on triheptanoin vs medium chain triglycerides in adults with refractory epilepsy. Epilepsia Open. 2019;4:153-163. (Among 34 adults with refractory epilepsy treated with titrated triheptanoin or conventional medium-chain triglycerides for 15 weeks, there were no differences in rates or changes in seizure frequency or in rates of adverse events and all blood tests showed no clinically significant changes). 30868125
Shirley M. Triheptanoin: First Approval. Drugs. 2020;80:1595-1600. (Review of the structure, mechanism of action, history of development, clinical efficacy, and safety of triheptanoin shortly after its approval for use in the US, mentions that it is “generally well tolerated” and that most adverse events are mild-to-moderate [diarrhea, abdominal pain, nausea and vomiting], or are due to the underlying condition [fatigue, rhabdomyolysis, myalgia]; no mention of ALT elevations or hepatotoxicity). 32897506
Vockley J, Burton B, Berry G, Longo N, Phillips J, Sanchez-Valle A, Chapman K, et al. Effects of triheptanoin (UX007) in patients with long-chain fatty acid oxidation disorders: Results from an open-label, long-term extension study. J Inherit Metab Dis. 2021;44:253-263. (Among 75 patients with LC-FAOD enrolled in a 24-week controlled trial of triheptanoin vs MCT and then into a long term, open label study, the annualized rate of major clinical events [rhabdomyolysis, hypoglycemia, cardiomyopathy] decreased by 45% in those continued on triheptanoin and by 70% of those started de novo on the supplement, and while adverse event rates were high [99%], they were usually unrelated to therapy, and there were “no noteworthy changes in ...chemistry… laboratory values”). 32885845
Striano P, Auvin S, Collins A, Horvath R, Scheffer IE, Tzadok M, Miller I, et al. A randomized, double-blind trial of triheptanoin for drug-resistant epilepsy in glucose transporter 1 deficiency syndrome. Epilepsia. 2022;63:1748-1760. (Among 36 children, adolescents and adults with drug resistant seizures associated with glucose transporter 1 deficiency treated with triheptanoin or placebo for 8 weeks followed by open label triheptanoin for up to one year, there was a 13% reduction in seizures in triheptanoin treated subjects related to baseline and placebo, but adverse events were more frequent including diarrhea, abdominal pain, nausea and vomiting, while there were no treatment related serious adverse events and routine laboratory testing showed no “clinically significant changes”). 35441706
Lasio MLD, Leshinski AC, Ducich NH, Flore LA, Lehman A, Shur N, Jayakar PB, et al. Clinical, biochemical and molecular characterization of 12 patients with pyruvate carboxylase deficiency treated with triheptanoin. Mol Genet Metab. 2023;139:107605. (Among 12 subjects with pyruvate carboxylase deficiency treated with triheptanoin for variable periods [6 days to 7 years], there was considerable variability in clinical responses [lactate and amino acid levels, quality of life scores] but it was “found to be safe and with no serious adverse events”, although dose adjustments were sometimes needed for gastrointestinal intolerance). 37207470
Vockley J, Burton BK, Berry G, Longo N, Phillips J, Sanchez-Valle A, Chapman KA, et al. Triheptanoin for the treatment of long-chain fatty acid oxidation disorders: Final results of an open-label, long-term extension study. J Inherit Metab Dis. 2023;46:943-955. (In a final report of long term [3-4 years], open label therapy with triheptanoin for LC-FAODs, the overall adverse event rate was 97% and serious adverse event rate 75%, but most adverse events were related to the underlying disease and there were no liver related serious adverse events and no mention of ALT elevations). 37276053
De Giorgis V, Bhatia KP, Boespflug-Tanguy O, Gras D, Marina AD, Desurkar A, Toledo M, et al. Triheptanoin did not show benefit versus placebo for the treatment of paroxysmal movement disorders in glut1 deficiency syndrome: results of a randomized phase 3 study. Mov Disord. 2024 May 9. Epub ahead of print. (Among 43 patients with paroxysmal movement disorders due to Glut1 deficiency syndrome treated with triheptanoin or placebo for 10 weeks, there were no differences in rates of disabling movement events or in adverse event rates [93% vs 81%], which were mostly diarrhea, nausea and vomiting and abdominal pain while serious adverse events were uncommon and unrelated; no mention of ALT elevations or hepatotoxicity). 38725190

## OTHER REFERENCE LINKS

Recent References on Triheptanoin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Triheptanoin+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Triheptanoin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Triheptanoin)